# Hyssop

## OVERVIEW

### Introduction

Hyssop is an herb prepared from the leaves and flowers of Hyssopus officinalis and is used for alleviation of symptoms of gastrointestinal and respiratory tract infections and the common cold. Hyssop is widely used and has not been implicated in causing liver injury.

### Background

Hyssop is an herb prepared from the aerial parts of the plant Hyssopus officinalis, which is a member of the mint family indigenous to Southern Europe and the Middle East. Hyssop has been used in folk medicine for centuries for stimulation of the circulation and for treatment of a variety of conditions including upper respiratory illness, asthma, cough, sore throat, intestinal infections, gastrointestinal upset, gall bladder disease, poor appetite, urinary tract infections and dysmenorrhea. Hyssop is also used topically in gargles, medicinal baths, and creams for skin irritation, burns and frostbite. Hyssop oil is used in cooking and as a fragrance in soaps and cosmetics. The constituents of hyssop extracts include volatile oils, tannins, bitters, and flavonoids. The volatile oils include pinocamphone, which is mildly toxic but may account for its apparent effect for respiratory symptoms. Hyssop oil is used as a fragrance and should not be taken orally. Hyssop extract is available as capsules and as liquid extracts, and it is taken two to three times daily. Side effects are mild and include gastrointestinal upset, anxiety and tremors. Hyssop may exacerbate seizure disorders, particularly in children when given as oil.

### Hepatotoxicity

Despite wide scale use, there is no evidence that Hyssop extracts cause liver injury and there have been no published reports of clinically apparent liver injury attributed to hyssop.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

Drug Class: Herbal and Dietary Supplements

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Hyssop – Generic

DRUG CLASS

Herbal and Dietary Supplements

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Hyssop | ID: 0977001630 | Herbal mixture | Not applicable

## ANNOTATED BIBLIOGRAPHY

References updated: 30 March 2018

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott,1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; hyssop is not discussed).
Seeff L, Stickel F, Navarro VJ. Hepatotoxicity of herbals and dietary supplements. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 631-58. (Review of hepatotoxicity of herbal and dietary supplements [HDS]; hyssop is not discussed).
Hyssop. In, PDR for Herbal Medicines. 4th ed. Montvale, New Jersey: Thomson Healthcare Inc. 2007: pp. 463. (Compilation of short monographs on herbal medications and dietary supplements).
Bunchorntavakul C, Reddy KR. Review article: herbal and dietary supplement hepatotoxicity. Aliment Pharmacol Ther 2013; 37: 3-17. (Review of HDS associated hepatotoxicity; does not mention hyssop). 23121117
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology 2014; 60:1399-408. (Among 85 cases of HDS associated liver injury [not due to anabolic steroids] enrolled in a US prospective study between 2004 and 2013, none were attributed to hyssop). 25043597
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury enrolled in a prospective database between 2004 and 2012, HDS were implicated in 145 [16%], none of which were due to hyssop: see Navarro [2014]). 25754159

## OTHER REFERENCE LINKS

1. Recent References on Hyssop: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Hyssop/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Hyssop: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Hyssop)